# Clindamycin

## OVERVIEW

### Introduction

Clindamycin is a broad spectrum antibiotic used orally, topically and parenterally for bacterial infections due to sensitive organisms. Clindamycin has been linked to rare instances of acute liver injury.

### Background

Clindamycin (klin" da mye' sin) is a lincomycin derivative with activity against many aerobic gram-positive cocci as well as many anaerobic gram-negative and gram-positive organisms. It has special activity against Bacteroides fragilis and some activity against Toxoplasma gondii and Pneumocystis jiroveci. Clindamycin acts by its binding to the 50S ribosomal subunit of bacteria, thus inhibiting protein synthesis. Clindamycin was approved for use in the United States in 1970 and is still in wide use with several million prescriptions being filled yearly. Current indications include moderate-to-severe bacterial infections caused by sensitive organisms. It is also used topically for acne and bacterial vaginosis. Clindamycin is available generically in oral and parenteral forms and as gels, foam, lotion and creams for topical use. Oral formulations include capsules of 75, 150 and 300 mg that are available in generic forms and under the commercial name of Cleocin. Clindamycin is also available in suspension for pediatric use. The typical adult dose is 600 to 2700 mg im or iv daily (in two divided doses) or 150 to 450 mg orally every 6 hours for 5 to 14 days, depending upon the type and severity of infection. Common side effects include nausea, diarrhea, headache and skin rash.

### Hepatotoxicity

Clindamycin has been linked to two forms of hepatotoxicity: transient serum aminotransferase elevations usually occurring after several days of high intravenous doses; and, an acute, idiosyncratic liver injury that arises within 1 to 3 weeks of starting therapy and is typically mild and self-limited.

High doses of intravenous clindamycin can be accompanied by elevations in serum ALT levels in the range of 2 to 10 times the upper limit of normal starting after 5 to 15 days of therapy in a manner similar to what occurs with intravenous oxacillin therapy (Case 1). Symptoms, jaundice, and alkaline phosphatase elevations are mild if they occur at all (Case 2), and aminotransferase levels rapidly fall into the normal range (in 1 to 2 weeks) upon stopping clindamycin or switching to lower doses or to oral formulations with which it rarely occurs.

Clindamycin therapy has also been linked to a clinically apparent, idiosyncratic liver injury that arises between 1 to 3 weeks after starting either oral or parenteral therapy (Case 3). The pattern of serum enzyme elevations is typically hepatocellular or mixed, but can be cholestatic. Allergic manifestations such as rash, fever and eosinophilia are typical, but often are not prominent and are not present in all cases. Autoantibodies are generally not present. The acute liver injury may accompany other signs of hypersensitivity such as Stevens Johnson syndrome or other severe skin reactions. The liver injury is usually mild-to-moderate in severity and resolves rapidly with stopping. However, fatal instances have been reported.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of ALT elevations during high dose clindamycin therapy is not known, but may be due to a direct but mild injury to the liver. Liver biopsy during these episodes generally shows minimal cell injury. The idiosyncratic reaction to clindamycin resembles the immunoallergic types of hepatitis that occur after many types of antibiotics, including the penicillins and cephalosporins.

### Outcome and Management

The serum aminotransferase elevations that appear during high dose intravenous therapy with clindamycin are usually benign, minimally symptomatic and resolve rapidly with stopping therapy or switching to oral forms of clindamycin. Acute idiosyncratic hepatitis can occur with either the parenteral or oral forms of clindamycin, but is rare. The liver injury can be symptomatic and prolonged and has been linked to one case of vanishing bile duct syndrome, but not with acute liver failure. Ordinarily, recovery can be expected in 4 to 8 weeks. Prednisone is not recommended. Patients should be told to avoid reexposure to clindamycin and other lincomycin derivatives.

Drug Class: Antiinfective Agents

## CASE REPORTS

### Case 1. Serum aminotransferase elevations during intravenous therapy with clindamycin.(1)

A 57 year old man with rheumatic heart disease and Staphylococcal endocarditis was treated with clindamycin (300 mg intravenously every 8 hours) and developed elevations in serum aminotransferase levels starting during the first week of therapy. Clindamycin was stopped at day 16 because of continuing elevations in ALT levels, which promptly began to fall when he was switched to cephalothin (Table). While blood cultures became negative on therapy, he subsequently died of E. coli sepsis.

#### Key Points

Medication: | Clindamycin, 300 mg IV every 8 hours
Pattern: | Probably hepatocellular
Severity: | 1+ (no jaundice)
Latency: | 5 days to AST elevations
Recovery: | Incomplete
Other medications: | None mentioned

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | AST (U/L) | LDH (U/L) | Other
Pre | | | 10 | 700
0 | | Clindamycin started (300 mg IV q 8 hr)
5 | | 55 | 70 | 1020
9 | | 310 | 320 | 1400
16 | | 510 | 600 | 2100
| 0 | Clindamycin stopped: cephalothin started
24 | 8 | 230 | 125 | 1420
Normal Values | | <40 | <40 | Not given

* Values estimated from Figure 1.

#### Comment

A typical pattern of serum aminotransferase elevations during intravenous clindamycin therapy that can be seen with several antibiotics, most typically with oxacillin. The liver injury usually arises after 4 to 6 days and is minimally symptomatic, anicteric and resolves rapidly when the antibiotic is stopped. The injury is probably dose related and a direct toxic effect of clindamycin or oxacillin.

### Case 2. Acute hepatitis arising during intravenous therapy with clindamycin.(2)

An 18 year old man with acute bacterial endocarditis related to injection drug use developed elevated serum aminotransferases and then jaundice during intravenous clindamycin therapy. The patient had been treated with high doses of cephalothin and vancomycin for over two months with an inadequate response, during which time his liver tests were normal. Blood cultures revealed Staphylococcus aureus sensitive to clindamycin, and he was started on intravenous clindamycin (3.6 g/day) with a rapid clinical improvement. After a week, however, serum AST levels began to rise. The dose of clindamycin was cut in half, but he subsequently developed urticaria, recurrence of fever, jaundice and rising AST levels (Table). Tests for hepatitis B were negative, and liver biopsy showed acute hepatitis without fibrosis compatible with a drug induced liver injury. Clindamycin was stopped and the rash, fever and jaundice promptly resolved. Follow up blood cultures were negative and serum AST levels were normal when tested one month later.

#### Key Points

Medication: | Clindamycin, 3.6 g iv daily for 30 days
Pattern: | Hepatocellular (R=9.1)
Severity: | 3+ (jaundiced and hospitalization prolonged)
Latency: | 8 days to AST elevations, 22 days to jaundice
Recovery: | Within one month
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
| | Clindamycin (3.6 gm IV daily) started for endocarditis
Pre | | 30 | 59 | 0.8
5 days | | 40
8 days | | 110
10 days | | 310
14 days | | 480 | | 1.5
16 days | | 710 | | | Reduced dose
3 weeks | | 750 | 80 | 3.5
4 weeks | | 80 | | 1.8 | Liver biopsy
| | Fever and urticaria: clindamycin stopped
5 weeks | 4 days | 50
6 weeks | 10 days | 80 | | 1.1
7 weeks | 18 days | 160 | Normal
2 months | 1 month | 30 | | 0.9
Normal Values | | <40 | <40 | <1.2

* Values estimated from Figure 1.

#### Comment

A typical pattern of serum aminotransferase elevations arising after a week of intravenous clindamycin therapy. The clindamycin dose was decreased because of the rising AST levels, but fever and urticaria arose, and clindamycin was stopped, whereupon the liver injury resolved rapidly. This example suggests that the asymptomatic elevations in serum aminotransferase levels during intravenous clindamycin therapy can evolve into the immunoallergic and icteric form of liver injury if therapy is continued. This report predated the availability of tests for hepatitis C, which may have been at least partially responsible for the liver injury in this patient.

### Case 3. Acute hepatitis with jaundice arising during clindamycin therapy.(3)

A 42 year old woman developed fatigue, nausea, anorexia, pruritus and dark urine followed by jaundice 6 days after starting a course of clindamycin (150 mg four times a day) for a gingival infection. She had received clindamycin for this same problem several times in the past without complications. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis and was taking no other medications. On presentation, she was jaundiced but without rash or fever. Laboratory testing showed an ALT of 1795 U/L, AST 1337 U/L, alkaline phosphatase 339 U/L, GGT 148 U/L, total bilirubin 4.1 mg/dL (direct 2.9 mg/dL) and INR 1.04. The eosinophil count was normal. Tests for hepatitis A, B and C and for cytomegalovirus and Epstein Barr virus infection were negative. Autoantibodies, including ANA, SMA and anti-LKM, were negative and an abdominal ultrasound showed no evidence of biliary obstruction. A liver biopsy showed cholestatic hepatitis without fibrosis, suggestive of drug induced liver injury. After 3 weeks, she was largely asymptomatic and all liver tests had returned to normal when she was seen 8 weeks after presentation (Table).

#### Key Points

Medication: | Clindamycin, 150 mg 4 times daily
Pattern: | Hepatocellular (R=44.9)
Severity: | 3+ (jaundiced and hospitalized)
Latency: | 6 days to symptoms
Recovery: | Within two months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
| | Clindamycin (150 mg qid) started for gingivitis
1 week | 0 | 1795 | 339 | 4.1 | Admission
2 weeks | 1 week | 1579 | 345 | 3.3 | Liver biopsy
4 weeks | 3 weeks | 754 | 175 | 1.8
9 weeks | 8 weeks | 28 | | 0.7
Normal Values | | <40 | <150 | <1.2

#### Comment

While referred to as “cholestatic” in the title of the publication, the clinical presentation was clearly hepatocellular and acute viral hepatitis-like arising after a week of clindamycin therapy. No other medications were being taken and other causes of liver injury were adequately excluded. The liver injury was clearly idiosyncratic and likely due to hypersensitivity, despite the absence of immunoallergic features (rash, fever and eosinophilia). Previous courses of clindamycin may have sensitized the patient to the antibiotic. Isolated instances of cross sensitivity have been reported between clindamycin and the penicillins and future use of related antibiotics should be done with care.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clindamycin – Generic, Cleocin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Clindamycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Clindamycin | 18323-44-9 | C18-H33-Cl-N2-O5-S

## CITED REFERENCES

1 (1977). Modified from Case #3: Hinthorn DR, Baker LH, Romig DA, Voth DW, Liu C. Endocarditis treated with clindamycin: relapse and liver dysfunction. South Med J.
2 Elmore M, Rissing JP, Rink L, Brooks GF. (1974). Clindamycin-associated hepatotoxicity. Am J Med.
3 Aygun C, Kocaman O, Gurbuz Y, Senturk O, Hulagu S. (2007). Clindamycin-induced acute cholestatic hepatitis. World J Gastroenterol.

## ANNOTATED BIBLIOGRAPHY

References updated: 16 December 2019

Zimmerman HJ. Clindamycin. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 592. (Expert review of liver injury published in 1999 mentions that ALT elevations are common during clindamycin therapy, and 2 cases of hepatocellular jaundice attributed to clindamycin have been published).
Moseley RH. Clindamycin. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470. (Expert review of antibiotic induced liver injury mentions that clindamycin has been rarely reported to cause hepatotoxicity).
MacDougall C. Lincosamides (Clindamycin). Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hillal-Dandan R, Knollman BA, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1056-7. (Textbook of pharmacology and therapeutics).
Elmore MF, Rink LD, Rissing JP. (1973). Clindamycin, endocarditis, hepatotoxicity. Ann Intern Med. (Letter to editor describing 18 year old injection drug user with acute bacterial endocarditis who developed marked AST elevation [710 U/L] after 18 days of iv clindamycin, resolving rapidly with stopping; 2 biopsies, first during therapy showed mild hepatitis, second during recovery showed resolution).
Fass RJ, Scholand JF, Hodges GR, Saslaw S. (1973). Clindamycin in the treatment of serious anaerobic infections. Ann Intern Med. (Analysis of responses to parenteral clindamycin in 19 adults with serious infections, 8 of who developed mild, transient ALT and AST or Alk P elevations, but none required discontinuation or developed jaundice).
Craig JA. (1974). Jaundice in acute pustular psoriasis. Br Med J. (62 year old woman developed jaundice 3 days after starting clindamycin therapy of sepsis [bilirubin 12.2 mg/dL, ALT normal]; likely due to sepsis rather than clindamycin).
Elmore M, Rissing JP, Rink L, Brooks GF. (1974). Clindamycin-associated hepatotoxicity. Am J Med. (18 year old injection drug use with acute bacterial endocarditis developed jaundice [3.5 mg/dL] and AST elevations [710 U/L] after 21 days of iv clindamycin, resolving rapidly once therapy was stopped; two biopsies done, first during therapy showed mild hepatitis, second during recovery showed resolution: Case 2).
Levison ME, Bran JL, Ries K. (1974). Treatment of anaerobic bacterial infections with clindamycin-2-phosphate. Antimicrob Agents Chemother. (Among 35 patients treated with clindamycin im or iv for severe bacterial infections, mild elevations in ALT, AST and Alk P were common, one patient developed hepatitis 1 day after stopping 12 day course of clindamycin [bilirubin 5.6 mg/dL, ALT 680 U/L, Alk P 460 U/L], resolving within 3-4 months of stopping).
Williams DN, Crossley K, Hoffman C, Sabath LD. (1975). Parenteral clindamycin phosphate: pharmacology with normal and abnormal liver function and effect on nasal staphylococci. Antimicrob Agents Chemother. (Open label study of parenteral clindamycin therapy in 41 patients including 24 with preexisting liver disease; AST levels rose in 5 patients with liver disease and improved in others; among 17 patients without liver disease, AST levels rose in 4 [52, 57, 60 and 270 U/L], but elevations were self-limited and resolved spontaneously).
Hinthorn DR, Baker LH, Romig DA, Voth DW, Liu C. (1977). Endocarditis treated with clindamycin: relapse and liver dysfunction. South Med J. (Among 6 patients treated for endocarditis with low rate of response, 2 developed ALT [~200 and 550 U/L], AST and LDH elevations after 8-18 days without jaundice or symptoms, resolving within 2 weeks of discontinuation: Case 1).
Kobayasi A, Sato S, Ito T, Utsumi T, Kikuchi N. (1977). Jpn J Antibiot. (From abstract: Among 11 patients given oral clindamycin for up to 49 days, one developed transient ALT elevations).
(1983). Prospective, randomized comparison of metronidazole and clindamycin, each with gentamicin, for the treatment of serious intra-abdominal infection. Surgery. (Multicenter study comparing clindamycin to metronidazole in 186 patients with severe infections; similar efficacy, AST elevations in 18% vs 10%, but no frank hepatitis or discontinuation for liver injury).
Altraif I, Lilly L, Wanless IR, Heathcote J. (1994). Cholestatic liver disease with ductopenia (vanishing bile duct syndrome) after administration of clindamycin and trimethoprim-sulfamethoxazole. Am J Gastroenterol. (Two cases of vanishing bile duct syndrome, one due to clindamycin: a 67 year old man with jaundice arising 1 week after completion of a 10 day course [bilirubin 14.6 mg/dL, ALT 315 U/L, Alk P 271 U/L, GGT 468 U/L], followed by prolonged jaundice for 2-4 years [bilirubin 4.2 mg/dL, Alk P 179 U/L, ALT 67 U/L], liver biopsies showing progressive loss of bile ducts; ampicillin caused sudden worsening).
Maraqa NF, Gomez MM, Rathore MH, Alvarez AM. (2002). Higher occurrence of hepatotoxicity and rash in patients treated with oxacillin, compared with those treated with nafcillin and other commonly used antimicrobials. Clin Infect Dis. (Retrospective review of 222 children receiving outpatient parenteral antibiotics; 22% receiving oxacillin, but only 1 of 72 receiving clindamycin developed “hepatitis” [at 17 days: bilirubin 0.6 mg/dL, ALT 183 U/L, AP normal]).
De Valle MB, Av Klinteberg V, Alem N, Olsson R, Björnsson E. (2006). Drug-induced liver injury in a Swedish University hospital out-patient hepatology clinic. Aliment Pharmacol Ther. (Survey of 77 cases of drug induced liver injury seen over 10 years, found 2 cases of clindamycin related injury, both hepatocellular, with onset after 7 and 35 days, resolution in 2 weeks and 6 months).
Aygun C, Kocaman O, Gurbuz Y, Senturk O, Hulagu S. (2007). Clindamycin-induced acute cholestatic hepatitis. World J Gastroenterol. (42 year old woman developed jaundice and pruritus after 6 days of oral clindamycin [bilirubin 4.1 mg/dL, ALT 1795 U/L, Alk P 339 U/L], resolving within 8 weeks of stopping).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, clindamycin was implicated in one case).
Flores Sahagun JE, Ortiz Soto JA, Mendez T, Cardenas Ochoa EC, Hernandez Flores G. (2009). Dermatology Online J. (48 year old woman developed jaundice at the end of an 8 day course of clindamycin and chlorpheniramine [bilirubin 3.5 mg/dL, ALT 1105 U/L, Alk P 444 U/L], with an accompanying rash that spread to mouth, palms and soles, responding to corticosteroids with rapid recovery within weeks).
Leitner JM, Graninger W, Thalhammer F. (2010). Hepatotoxicity of antibacterials: Pathomechanisms and clinical. Infection. (Review of frequency and cause of antibiotic induced liver injury, rates range from 0.2 [moxifloxacin] to 17 [amoxicillin/ clavulanate] per 100,000 prescriptions for different commonly implicated agents; mentions that clindamycin most frequently causes asymptomatic increases in ALT).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 31 due to antibiotics, but none were attributed to clindamycin).
Bawany MZ, Bhutto B, Youssef WI, Nawras A, Sodeman T. (2011). Acute liver failure: an uncommon complication of commonly used medication. Am J Ther. (73 year old man developed jaundice 7 days after starting clindamycin [bilirubin 6.9 mg/dL, ALT 1076 U/L, Alk P 203 U/L, INR 2.1], liver tests improved on stopping, but patient developed respiratory followed by multiorgan failure and died soon thereafter).
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. (2012). Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 6 [1.1%] attributed to clindamycin).
Miller Quidley A, Bookstaver PB, Gainey AB, Gainey MD. (2012). Fatal clindamycin-induced drug rash with eosinophilia and systemic symptoms (DRESS) syndrome. Pharmacotherapy. (63 year old woman developed nausea and a generalized erythematous rash 4 days after starting a course of clindamycin, with subsequent fever, eosinophilia [24%], lymphadenopathy, renal dysfunction, pancreatitis, and liver injury [bilirubin 4.3 mg/dL, ALT 67 U/L, Alk P 1010 U/L], with progressive multiorgan failure and death 16 days after presentation).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, of which none were attributed to clindamycin).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, including 39 attributed to antimicrobial agents, but none to clindamycin).
Lim R, Choudry H, Conner K, Karnsakul W. (2014). A challenge for diagnosing acute liver injury with concomitant/sequential exposure to multiple drugs: can causality assessment scales be utilized to identify the offending drug?. Case Rep Pediatr. (12 year old boy with severe cellulitis received amoxicillin, ceftriaxone, vanocmycin, ampicillin/sulbactam and clindamycin, whereupon he developed fever and jaundice [bilirubin 3.0 rising to 11.8 mg/dL, ALT 406 U/L, Alk P 404 U/L], resolving slowly and incompletely by 6 months; causality was complicated by polypharmacy, but authors attributed the injury to clindamycin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including two due to clindamycin; both with jaundice [initial bilirubin 3.4 and 6.4 mg/dL], one being hepatocellular, one mixed, both self limited).
Moole H, Ahmed Z, Saxena N, Puli SR, Dhillon S. (2015). Oral clindamycin causing acute cholestatic hepatitis without ductopenia: a brief review of idiosyncratic drug-induced liver injury and a case report. J Community Hosp Intern Med Perspect. (75 year old woman developed jaundice while receiving a 10 day course of clindamycin [bilirubin 9.2 rising to 25 mg/dL, ALT 227 U/L, Alk P 296 U/L, INR 1.5 rising to 2.5], resolving within 4 weeks on prednisone therapy).
Okudo J, Anusim N. (2016). Hepatotoxicity due to clindamycin in combination with acetaminophen in a 62-year-old African American female: a case report and review of the literature. Case Reports Hepatol. (62 year old woman developed liver test abnormalities 5 days after starting clindamycin [bilirubin normal, ALT 423, Alk P 321 U/L] and rose while it was continued [peak ALT 1927 U/L], with improvement on stopping).
Munz M, Grummich H, Birkmann J, Wilhelm M, Holzgrabe U, Sörgel F. (2017). Severe drug-induced liver injury as an adverse drug event of antibiotics: a case report and review of the literature. Chemotherapy. (20 year old woman developed jaundice having recently received courses of amoxicillin, cefazolin and clindamycin [bilirubin 3.7 rising to 16.9 mg/dL, ALT 1219 U/L, Alk P 143 U/L, INR 1.57 rising to 2.6], with progressive liver failure but eventual spontaneous recovery with normal liver tests 2 months later).
Hoofnagle JH, Björnsson ES. (2019). Drug-induced liver injury - types and phenotypes. N Engl J Med. (Review of the clinical features, diagnosis, complications and pathogenesis of different forms of drug induced liver injury mentions that antibiotics are the most common medications causing liver injury, but they are also the most common class of medications approved for use in the US).

## OTHER REFERENCE LINKS

1 Recent References on Clindamycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=clindamycin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/09%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Clindamycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=clindamycin)